# Tramadol

## OVERVIEW

### Introduction

Tramadol is an opioid analgesic used for the therapy of mild-to-moderate pain. Tramadol overdose can cause acute liver failure. Pharmacologic doses of tramadol has not been associated with cases of clinically apparent drug induced liver disease.

### Background

Tramadol is a synthetic codeine analog that acts as a weak opioid agonist in addition to mildly inhibiting serotonin and norepinephrine reuptake. Tramadol is effective against mild-to-moderate pain, but is not as effective as standard opioids and not recommended for severe pain. Tramadol was approved for use in the United States in 1995 and is currently widely used, with more than 18 million prescriptions written yearly. Tramadol is available in 50 mg tablets in multiple generic forms and under the brand name Ultram. It is also available as tablets of 37.5 mg in combination with acetaminophen (325 mg) both generically and under the brand name Ultracet. The usual dose in adults is initially 25 mg daily, with titration based on effect and tolerance to 50 to 100 mg every 4 to 6 hours as needed for pain, but not to exceed 400 mg daily. Extended release formulations in capsules of 100, 200 and 300 mg are also available (ConZip and generics) and are given once daily. Physical dependence can occur, and while the potential for abuse is less than with more typical opioid analgesics, tramadol is classified as a schedule IV drug and is provided under a risk evaluation and mitigation strategy (REMS). Common side effects are nausea, dizziness, dry mouth, sedation and headache. Tramadol may increase the risk of seizures. It is considered contraindicated in children below the age of 12 because of risk of respiratory depression, and prolonged use should be avoided in pregnancy because of the risk of infant withdrawal syndrome. Rare but potentially severe adverse events include seizures, severe respiratory depression, serotonin syndrome, addiction, abuse and withdrawal syndrome.

### Hepatotoxicity

Serum aminotransferase levels can be elevated in a small proportion of patients receiving tramadol, particularly with high doses. Intentional and accidental overdoses of tramadol can cause respiratory arrest as well as acute liver failure, several fatal instances of which have been reported. In these cases, however, the liver injury may have been caused by shock, hypoxia or ischemia secondary to the respiratory arrest. Liver injury attributed to tramadol overdose has also been associated with hyperammonemia, lactic acidosis and hepatic steatosis, suggestive of direct mitochondrial injury. In some situations, acute liver failure after tramadol overdose may be related to acetaminophen taken separately or in combination with tramadol. Clinically apparent idiosyncratic liver injury with recommended doses of tramadol has not been reported.

Likelihood score: E* (unproven cause of liver injury in therapeutic doses but reported to cause liver injury with overdose).

### Mechanism of Injury

The mechanism of hepatotoxicity from overdoses of tramadol is not known, but is likely due to direct hepatocellular injury, either as a result of ischemia or mitochondrial toxicity. Tramadol is metabolized by the liver, predominantly by CYP 2D6 and 3A4 to its active form and it can result in troublesome drug-drug interactions.

### Outcome and Management

The minor enzyme elevations that occur with tramadol use are usually mild, asymptomatic and self-limited, resolving even with continuation of therapy. Cases of acute liver failure due to tramadol overdose require intensive medical management and can be fatal. In acute overdoses, there may be interaction with other agents capable of causing liver injury (particularly acetaminophen).

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tramadol – Generic, Ultram®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tramadol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tramadol | 27203-92-5 | C16-H25-N-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 24 November 2020

Zimmerman HJ. Nonsteroidal anti-inflammatory drugs. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Textbook of hepatotoxicity published in 1999; tramadol is not discussed).
Yaksh T, Wallace M. Opioids, analgesia, and pain management. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 355-386. (Textbook of pharmacology and therapeutics).
Lewis KS, Han NH. (1997). Tramadol: a new centrally acting analgesic. Am J Health Syst Pharm. (Review of pharmacology, efficacy and side effects of tramadol in management of pain; extensively metabolized in the liver, largely through CYP 2D6; adverse events in 15%, but no mention of hepatic effects).
Cossmann M, Kohnen C, Langford R, McCartney C. (1997). Drugs. (Extensive review of side effects of tramadol from phase II-IV studies in 21,000 patients from 1977-93; little evidence of respiratory depression or dependence with oral administration; no mention of hepatotoxicity).
Bamigbade TA, Langford RM. (1998). Tramadol hydrochloride: an overview of current use. Hosp Med. (Review of mechanism of action, pharmacology and uses of tramadol).
Tolman KG. (1998). Hepatotoxicity of non-narcotic analgesics. Am J Med. (Review of liver injury due to analgesics; states that tramadol has not been reported to cause hepatic injury).
Musshoff F, Madea B. (2001). Fatality due to ingestion of tramadol alone. Forensic Sci Int. (26 year old man found dead after tramadol overdose; autopsy showed brain edema, no mention of liver).
(2002). Highlights of the 22nd French pharmacovigilance meeting. Prescrire Int. (Tramadol reported to interact with warfarin leading to marked increases in INR and bleeding).
Loughrey MB, Loughrey CM, Johnston S, O'Rourke D. (2003). Fatal hepatic failure following accidental tramadol overdose. Forensic Sci Int. (Accidental tramadol overdose in 67 year old man taking ~1000 mg daily for 8 days, presenting with respiratory failure, stupor and liver injury [bilirubin 3.3 mg/dL, ALT 1739 U/L, Alk P 89 U/L, lactic acidosis and hypoglycemia], dying after cardiopulmonary arrest and possibly ischemic hepatic injury).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to tramadol).
De Decker K, Cordonnier J, Jacobs W, Coucke V, Schepens P, Jorens PG. (2008). Fatal intoxication due to tramadol alone: case report and review of the literature. Forensic Sci Int. (28 year old man with acute tramadol overdose suffered cardiopulmonary arrest, was resuscitated, but died two days later with acute liver and renal failure and hyperammonemia; liver biopsy showed steatosis and centrolobular ischemic necrosis).
Leppert W. (2009). Tramadol as an analgesic for mild to moderate cancer pain. Pharmacol Rep. (Review of mechanism of action, pharmacology, efficacy and safety of tramadol in mild-to-moderate cancer pain; side effects occur in 1-6% of patients, but serious adverse effects are very rare; hepatotoxicity and ALT abnormalities are not discussed).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to tramadol).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to tramadol).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to tramadol, other opiates or opiate antagonists).
(2017). FDA warns against use of codeine and tramadol in children and breastfeeding women. Med Lett Drugs Ther. (Concise summary of revised FDA recommendations on use of tramadol in children listing it as contraindicated in those below the age of 12 because of risk of severe respiratory depression, cautioning its use in adolescents because of addiction and abuse, and avoidance of prolonged use in pregnant women because of potential of withdrawal syndrome in newborns; no mention of ALT elevations or hepatotoxicity).
(2018). Opioids for pain. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of opioids used for pain relief, discusses adverse events or short and long term use of tramadol, but makes no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Tramadol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tramadol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tramadol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tramadol)